# Boceprevir

## OVERVIEW

### Introduction

Boceprevir is an oral, direct acting hepatitis C virus (HCV) protease inhibitor that was used in combination with peginterferon and ribavirin in the treatment of chronic hepatitis C, genotype 1. Initially approved for use in 2012, it was withdrawn in 2015 because of the availability of more effective and better tolerated all oral regimens of direct acting antiviral agents. Boceprevir was not linked to instances of acute liver injury during therapy but, when combined with peginterferon and ribavirin, was associated with cases of hepatic decompensation in patients with preexisting cirrhosis.

### Background

The hepatitis C virus is a small RNA virus that is a major cause of chronic hepatitis, cirrhosis and hepatocellular carcinoma in the United States as well as worldwide. Various approaches to antiviral therapy of chronic hepatitis C have been developed, starting in the 1980s with interferon alfa which was replaced in the 1990s by long acting forms of interferon (peginterferon) to which was added the oral nucleoside analogue, ribavirin. Between 2010 and 2015, several potent oral, direct acting anti-HCV agents were developed and combinations of these found to have marked activity against the virus, allowing for highly effective therapy without use of interferon with treatment courses of 8 to 24 weeks only. These direct acting agents included HCV protease (NS3/4) inhibitors, structural replication complex (NS5A) inhibitors and the HCV RNA polymerase (NS5B) inhibitors. The HCV protease inhibitors block the activity of the viral encoded protease that is essential in the posttranslational modification of the viral polypeptide, cleaving it into a series of structural and nonstructural (NS: enzyme) regions. The HCV proteases that have been developed are polypeptide-like molecules, modified amino acids that that resemble the specific amino acid sequence that the protease cleaves and act as competitive inhibitors of the protease enzyme. At least seven HCV protease inhibitors (all having the suffix: -previrs) have been approved for use in the United States: boceprevir [2012: Victrelis], telaprevir [2012, Incevek], simeprevir [2013, Olysio], paritaprevir [2014, Viekira Pak], grazoprevir [2016, Zepatier], glecaprevir [2017: Mavyret], and Voxilaprevir [2017: Vosevi].

Boceprevir (boe se' pre vir) was one of the first direct acting agents developed as therapy of hepatitis C. Like other HCV protease inhibitors, boceprevir blocks the activity of the viral encoded protease (HCV nonstructural [NS] region 3/4) that is essential in the posttranslational modification of the viral polypeptide, that is cleaved into a series of structural and nonstructural (enzyme) regions. When used by itself, it results in rapid inhibition of HCV RNA levels, but resistance develops rapidly in a high proportion of patients. When combined with peginterferon and ribavirin, it was shown to provide a sustained inhibition of HCV RNA with a low rate of antiviral resistance. Triple therapy with boceprevir, peginterferon and ribavirin, when given for 44 to 48 weeks, increased the sustained virological response (SVR) rate from 40% to 50% (peginterferon and ribavirin alone) to 65% to 75% in patients with genotype 1. Boceprevir was approved for use in the United States in 2012 under the brand name Victrelis for patients with chronic hepatitis C, genotype 1, in combination with peginterferon and ribavirin. The recommended dose was 800 mg three times daily. Because of the development and availability of more potent and better tolerated regimens of antiviral agents that could be given without peginterferon, boceprevir was voluntarily discontinued in 2015. The side effects of boceprevir were difficult to separate from those of the coadministered peginterferon and ribavirin, but the triple therapy was associated with a higher rate of many side effects, including anemia, fatigue, headache, nausea, itching, rash and neutropenia.

### Hepatotoxicity

In large randomized controlled trials, triple therapy with boceprevir, peginterferon and ribavirin was associated with a high rate of adverse events that often required dose adjustments and led to early discontinuation in 5% to 20% of patients. However, serum ALT elevations and clinically apparent liver injury were not generally mentioned as adverse events of therapy. The exception to this occurred in patients with preexisting cirrhosis in whom de novo, seemingly spontaneous hepatic decompensation occurred in a proportion of treated subjects. The cause of the decompensation was not clear and the separate role of boceprevir from peginterferon and ribavirin and from what might happen even without therapy could not be easily defined. Nevertheless, in postmarketing studies of triple therapy of chronic hepatitis C with cirrhosis, decompensation was reported in 3% to 8% of patients and deaths from hepatic failure in 1% to 3%.

Likelihood score for the combination of boceprevir, peginterferon and ribavirin: B (likely cause of liver injury and hepatic decompensation in patients with preexisting cirrhosis or advanced fibrosis).

### Mechanism of Injury

The mechanism by which boceprevir might cause liver injury is not known. It is metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 3A4. It is also a substrate of P-glycoprotein (P-gp). It is susceptible to drug-drug interactions, but largely for those agents that have major effects or are highly dependent upon CYP 3A4 and P-gp for their metabolism. In addition, the other adverse effects of boceprevir, particularly when combined with peginterferon and ribavirin, may predispose to events that might lead to hepatic decompensation in a susceptible patient. Triple therapy is associated with a high rate of anemia, neutropenia, thrombocytopenia, infection, gastrointestinal upset, dehydration and rash, all of which might help precipitate hepatic decompensation in a patient with underlying cirrhosis or advanced fibrosis.

### Outcome and Management

Triple therapy using boceprevir is no longer used, but it was considered inadvisable in patients with preexisting cirrhosis, particularly those with a prior history of hepatic decompensation. A similar high rate of decompensation of preexisting cirrhosis was reported with triple therapy using telaprevir and simeprevir, two other HCV protease inhibitors. In fact, hepatic decompensation was also a reported complication of all-oral antiviral therapy of hepatitis C, although the rates reported with non-interferon and non-ribavirin containing regimens were quite low (<1%).

Drug Class: Antiviral Agents, Hepatitis C Agents, HCV Protease Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Boceprevir – Victrelis®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Boceprevir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Boceprevir | 394730-60-0 | C27-H45-N5-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 26 January 2022

Abbreviations used: HCV, hepatitis C virus; HIV, human immunodeficiency virus; SVR, sustained virological response.

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss oral, direct acting antiviral agents used to treat hepatitis C).
Kim JL, Morgenstern KA, Lin C, Fox T, Dwyer MD, Landro JA, Chambers SP, et al. (1996). Crystal structure of the hepatitis C virus NS3 protease domain complexed with a synthetic NS4A cofactor peptide. Cell. (Report of the crystal structure of the NS3/4 region of HCV with detailed description of the active serine protease catalytic site, the target for subsequent development of specific inhibitors of the HCV protease).
Poordad F, McCone J, Bacon BR, Bruno S, Manns MP, Sulkowski MS, Jacobson IM, et al. (2011). SPRINT-2 Investigators. Boceprevir for untreated chronic HCV genotype 1 infection. N Engl J Med. (Among 1097 patients with previously untreated chronic hepatitis C, genotype 1, who were treated with peginterferon and ribavirin with vs without boceprevir for up to 48 weeks, SVR rates were higher with boceprevir [63-66% vs 38%], while serious adverse event rates were similar [11%-12% vs 9%] and there were no liver related serious events).
Bacon BR, Gordon SC, Lawitz E, Marcellin P, Vierling JM, Zeuzem S, Poordad F, et al., HCV RESPOND-2 Investigators. (2011). Boceprevir for previously treated chronic HCV genotype 1 infection. N Engl J Med. (Among 403 patients with previously treated chronic hepatitis C, genotype 1, who received peginterferon and ribavirin with vs without boceprevir for up to 48 weeks, SVR rates were higher with boceprevir [59% and 66% vs 21%], as were rates of serious adverse events [10% to 14% vs 5%], one patient on boceprevir developing hepatic encephalopathy).
(2011). Telaprevir (Incivek) and boceprevir (Victrelis) for chronic hepatitis C. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of boceprevir and telaprevir shortly after their approval for use as a part of triple therapy of chronic hepatitis C, genotype 1, in the US, mentions side effects of rash, anemia, fatigue, pruritus, nausea and anorectal pruritus and burning, but not ALT elevations or clinically apparent liver injury).
Bruno S, Vierling JM, Esteban R, Nyberg LM, Tanno H, Goodman Z, Poordad F, et al. (2013). Efficacy and safety of boceprevir plus peginterferon-ribavirin in patients with HCV G1 infection and advanced fibrosis/cirrhosis. J Hepatol. (In a post hoc analysis of 178 patients with chronic hepatitis C, genotype 1, and advanced fibrosis or cirrhosis who were treated with peginterferon and ribavirin with or without boceprevir for up to 48 weeks in previous trials, serious adverse events occurred in 11-16% of patients and most “were associated with advancing chronic hepatitis C”).
Hézode C, Fontaine H, Dorival C, Larrey D, Zoulim F, Canva V, de Ledinghen V, et al., CUPIC Study Group. (2013). Triple therapy in treatment-experienced patients with HCV-cirrhosis in a multicentre cohort of the French Early Access Programme(ANRS CO20-CUPIC) - NCT01514890. J Hepatol. (Among 497 patients with chronic hepatitis C, genotype 1, and cirrhosis treated in a French early access program with 48 weeks of peginterferon and ribavirin with either boceprevir or telaprevir, serious adverse events occurred in 197 patients [40%], hepatic decompensation in 12 [2.4%], severe infection in 24 [4.8%], and 6 patients died [1.5%], the serious complications typically arising in the first 12 weeks of therapy).
Sulkowski M, Pol S, Mallolas J, Fainboim H, Cooper C, Slim J, Rivero A, et al. (2013). P05411 study investigators. Boceprevir versus placebo with pegylated interferon alfa-2b and ribavirin for treatment of hepatitis C virus genotype 1 in patients with HIV: a randomised, double-blind, controlled phase 2 trial. Lancet Infect Dis. (Among 98 patients with chronic hepatitis C, genotype 1, and HIV coinfection treated with peginterferon and ribavirin with vs without boceprevir for up to 48 weeks, SVR rates were higher with boceprevir [63% vs 29%], but serious adverse events rates were similar; no mention of liver related events or ALT elevations).
Coilly A, Roche B, Dumortier J, Leroy V, Botta-Fridlund D, Radenne S, Pageaux GP, et al. (2014). Safety and efficacy of protease inhibitors to treat hepatitis C after liver transplantation: a multicenter experience. J Hepatol. (Among 37 patients with severe recurrent chronic hepatitis C, genotype 1, after liver transplant who were treated with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, 6 [16%] had an SVR, 10 [27%] a severe infection and 3 [8%] died).
Manns MP, McCone J, Davis MN, Rossaro L, Schiff E, Shiffman ML, Bacon B, et al. (2014). Overall safety profile of boceprevir plus peginterferon alfa-2b and ribavirin in patients with chronic hepatitis C genotype 1: a combined analysis of 3 phase 2/3 clinical trials. Liver Int. (Combined analysis of 3 trials of peginterferon and ribavirin with vs without boceprevir in 2095 patients with chronic hepatitis C, genotype 1, found similar rates of adverse events, but more anemia and dysgeusia with boceprevir).
Park C, Jiang S, Lawson KA. (2014). Efficacy and safety of telaprevir and boceprevir in patients with hepatitis C genotype 1: a meta-analysis. J Clin Pharm Ther. (Analysis of efficacy and safety of telaprevir and boceprevir in triple therapy in 10 controlled trials of 4421 patients with chronic hepatitis C, genotype 1; serious adverse events were higher with triple therapy than with peginterferon and ribavirin alone).
Schinazi R, Halfon P, Marcellin P, Asselah T. (2014). HCV direct-acting antiviral agents: the best interferon-free combinations. Liver Int. (Summary of safety and efficacy of various all-oral regimens for therapy of hepatitis C does not discuss hepatic decompensation, hepatotoxicity or ALT elevations during therapy).
Vierling JM, Zeuzem S, Poordad F, Bronowicki JP, Manns MP, Bacon BR, Esteban R, et al. (2014). Safety and efficacy of boceprevir/peginterferon/ribavirin for HCV G1 compensated cirrhotics: meta-analysis of 5 trials. J Hepatol. (Among 212 patients with cirrhosis due to chronic hepatitis C, genotype 1, treated with peginterferon and ribavirin with vs without boceprevir in 5 clinical trials, SVR rates were higher with boceprevir [55% vs 17%], but hepatic decompensation and/or sepsis occurred in 5 [2.5%] patients among whom 1 died).
Hézode C, Fontaine H, Dorival C, Zoulim F, Larrey D, Canva V, De Ledinghen V, et al., CUPIC Study Group. (2014). Effectiveness of telaprevir or boceprevir in treatment-experienced patients with HCV genotype 1 infection and cirrhosis. Gastroenterology. (Among 511 patients with cirrhosis and chronic hepatitis C, genotype 1, and cirrhosis treated with triple therapy using telaprevir or boceprevir for 48 weeks, 91 [18%] patients had an SVR, severe adverse events occurred in 50%, including liver decompensation in 43 [8%], severe infections in 28 [5.5%] and death in 11 [2.2%]).
Burton JR, O'Leary JG, Verna EC, Saxena V, Dodge JL, Stravitz RT, Levitsky J, et al. (2014). A US multicenter study of hepatitis C treatment of liver transplant recipients with protease-inhibitor triple therapy. J Hepatol. (Among 81 patients with recurrent hepatitis C, genotype 1, after liver transplant who were treated with triple therapy using peginterferon, ribavirin and either boceprevir or telaprevir, the overall SVR rate was 63%, the serious adverse event rate was not reported, but 27% required hospitalization, 15% early drug discontinuation and 7 patients [9%] died of liver failure).
Gordon SC, Muir AJ, Lim JK, Pearlman B, Argo CK, Ramani A, Maliakkal B, et al., HCV-TARGET study group. (2015). Safety profile of boceprevir and telaprevir in chronic hepatitis C: real world experience from HCV-TARGET. J Hepatol. (Among 2084 patients with chronic hepatitis C, genotype 1, treated in clinical practice with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, the overall SVR rate was 52%, serious adverse event rate 12%, while hepatic decompensation occurred in 3% and 5 patients [0.25%] died all from hepatic failure; rash was a common side effect [63% with telaprevir and 34% with boceprevir] and was graded as serious in 8 patients [0.5%], 2 [0.1%] with DRESS).
Verna EC, Saxena V, Burton JR, O'Leary JG, Dodge JL, Stravitz RT, Levitsky J, et al. (2015). CRUSH-C Consortium. Telaprevir- and boceprevir-based triple therapy for hepatitis C in liver transplant recipients with advanced recurrent disease: a multicenter study. Transplantation. (Among 54 patients with advanced, recurrent chronic hepatitis C, genotype 1, after liver transplantation, who were treated with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, the SVR rate was 50%, but hepatic decompensation arose in 24% and 6 patients [11%] died).
Neukam K, Munteanu DI, Rivero-Juárez A, Lutz T, Fehr J, Mandorfer M, Bhagani S, et al. (2015). Boceprevir or telaprevir based triple therapy against chronic hepatitis C in HIV coinfection: real-life safety and efficacy. PLoS One. (Among 159 patients with chronic hepatitis C, genotype 1, treated in health care clinics in 5 European countries with peginterferon, ribavirin and either boceprevir or telaprevir for up to 48 weeks, the overall SVR rate was 63%, while 4 patients [2.5%] developed hepatic decompensation, one of whom died of hepatic failure).
Manolakopoulos S, Kranidioti H, Goulis J, Vlachogiannakos J, Elefsiniotis J, Kouroumalis EA, Koskinas J, et al. (2015). Boceprevir for chronic HCV genotype 1 infection in treatment-experienced patients with severe fibrosis or cirrhosis: The Greek real-life experience. Ann Gastroenterol. (Among 25 Greek patients with chronic hepatitis C, genotype 1, and cirrhosis treated with peginterferon, ribavirin and boceprevir for up to 48 weeks, the SVR rate was 36%, but no patient developed hepatic decompensation or died).
Miailhes P, Gilbert C, Lacombe K, Arends JE, Puoti M, Rockstroh JK, Sogni P, et al., ESCMID European Study Group on Viral Hepatitis. (2015). Triple therapy with boceprevir or telaprevir in a European cohort of cirrhotic HIV/HCV genotype 1-coinfected patients. Liver Int. (Among 59 patients with chronic hepatitis C, cirrhosis and HIV-coinfection treated with peginterferon, ribavirin and either boceprevir [n=12] or telaprevir [n=47], the SVR rate was 36% vs 57%, and adverse events included rash [46% vs 8%] and hepatic decompensation [1 each]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but all were antiretroviral agents and no case was attributed to the oral direct acting agents used to treat hepatitis C).
Bailly F, Pradat P, Virlogeux V, Zoulim F. (2015). Antiviral Therapy in Patients with Hepatitis C Virus-Induced Cirrhosis. Dig Dis. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis summarizing the high rate of adverse events, including hepatic decompensation and death with peginterferon based regimens combined with boceprevir or telaprevir and the more effective and better tolerated all oral regimens).
Ferenci P, Kozbial K, Mandorfer M, Hofer H. (2015). HCV targeting of patients with cirrhosis. J Hepatol. (Review of the status of antiviral therapy of chronic hepatitis C with cirrhosis, suggests that genotype 1 infected patients should receive an all-oral regimen such as dual therapy using sofosbuvir with ledipasvir or daclatasvir or the triple combination of dasabuvir with ombitasvir and paritaprevir, the major issues being duration of therapy and the role of ribavirin).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
Sukeepaisarnjaroen W, Pham T, Tanwandee T, Nazareth S, Galhenage S, Mollison L, Totten L, et al. (2015). Boceprevir early-access for advanced-fibrosis/cirrhosis in Asia-Pacific hepatitis C virus genotype 1 non-responders/relapsers. World J Gastroenterol. (Among 150 patients with chronic hepatitis C, genotype 1, previous treatment failure who were treated with peginterferon, ribavirin and boceprevir, the SVR rate was 61% and serious adverse event rate 19%, which included 4 cases of hepatic decompensation [2.6%]).
Coilly A, Dumortier J, Botta-Fridlund D, Latournerie M, Leroy V, Pageaux GP, Agostini H, et al. (2015). Multicenter experience with boceprevir or telaprevir to treat hepatitis C recurrence after liver transplantation: when present becomes past, what lessons for future?. PLoS One. (Among 81 patients with recurrent hepatitis C after liver transplantation who were treated with peginterferon, ribavirin and either telaprevir or boceprevir, 38 [47%] had an SVR, 22 [27%] a serious adverse event, 10 [12%] acute rejection, and 4 [5%] died, largely of infectious complications; no mention of ALT elevations or hepatotoxicity).
Salmerón J, Vinaixa C, Berenguer R, Pascasio JM, Sánchez Ruano JJ, Serra MÁ, Gila A, et al., Alhambra Spanish Study Group. (2015). Effectiveness and safety of first-generation protease inhibitors in clinical practice: Hepatitis C virus patients with advanced fibrosis. World J Gastroenterol. (Among 1057 patients with chronic hepatitis C who were treated with peginterferon, ribavirin and either telaprevir or boceprevir at 38 Spanish hospitals, 635 [60%] had an SVR, and adverse events were largely hematologic; no mention of ALT elevations or hepatotoxicity).
Manolakopoulos S, Kranidioti H, Goulis J, Vlachogiannakos J, Elefsiniotis J, Kouroumalis EA, Koskinas J, et al. (2015). Boceprevir for chronic HCV genotype 1 infection in treatment-experienced patients with severe fibrosis or cirrhosis: The Greek real-life experience. Ann Gastroenterol. (Among 26 patients with chronic hepatitis C, genotype 1, and severe fibrosis or cirrhosis who were treated with peginterferon, ribavirin and boceprevir for 48 weeks, 9 [36%] had an SVR and side effects included anemia, thrombocytopenia, neutropenia, fatigue and diarrhea; no mention of ALT elevations or hepatotoxicity).
Hullegie SJ, Claassen MA, van den Berk GE, van der Meer JT, Posthouwer D, Lauw FN, Leyten EM, et al. (2016). Boceprevir, peginterferon and ribavirin for acute hepatitis C in HIV infected patients. J Hepatol. (Among 57 patients with acute hepatitis C, genotype 1, and HIV coinfection who were treated with a 12 week course of peginterferon, ribavirin and boceprevir, 49 [86%] had an SVR and no patient had a liver related serious adverse event or worsening of the acute hepatitis).
Ueda Y, Ikegami T, Soyama A, Akamatsu N, Shinoda M, Ishiyama K, Honda M, et al. (2016). Simeprevir or telaprevir with peginterferon and ribavirin for recurrent hepatitis C after living donor liver transplantation: A Japanese multicenter experience. Hepatol Res. (Among 79 patients with chronic hepatitis C, genotype 1, after liver transplantation who were treated with peginterferon, ribavirin and either simeprevir [n=79] or telaprevir [n=36], the SVR rates were 56% vs 69%, serious adverse event rates 11% vs 25%, and immune mediated graft dysfunction occurred in 8% vs 11%).
Ascione A, Adinolfi LE, Amoroso P, Andriulli A, Armignacco O, Ascione T, Babudieri S, et al., Cleo Study Group. (2016). Boceprevir or telaprevir in hepatitis C virus chronic infection: The Italian real life experience. World J Hepatol. (Among 834 patients treated with telaprevir or boceprevir combined with peginterferon and ribavirin enrolled in a multicenter Italian database, the SVR rate was 63% but adverse events were frequent and led to early discontinuation in 15%, largely for rash [31%], anemia [23%], weakness [14%] and other reasons included ascites in 3 patients, but ALT elevations and hepatic dysfunction were not mentioned).
Fontaine H, Maynard M, Bouix C, Carrieri MP, Botta-Fridlund D, D'Alteroche L, Conti F, et al., BOCEPRETRANSPLANT study group. (2017). Efficacy and safety of boceprevir-based triple therapy in HCV cirrhotic patients awaiting liver transplantation (ANRS HC29 BOCEPRETRANSPLANT). Clin Res Hepatol Gastroenterol. (Among 51 patients with chronic hepatitis C and cirrhosis awaiting liver transplantation who were treated with peginterferon, ribavirin and boceprevir, the SVR rate was only 16% [n=8] and 84% of patients discontinued therapy early due to adverse events or lack of response, 7 patients died, 3 attributed to therapy with major serious adverse event being infections).
Laguno M, Von Wichmann MA, Van den Eynde E, Navarro J, Cifuentes C, Murillas J, Veloso S, et al. (2016). Boceprevir plus pegylated interferon/ribavirin to re-treat hepatitis C virus genotype 1 in HIV-HCV co-infected patients: final results of the Spanish BOC HIV-HCV Study. Int J Infect Dis. (Among 98 patients with HIV/HCV coinfection treated with peginterferon, ribavirin and boceprevir, the overall SVR rate was 67% and serious adverse event rate 19% [33% in those with cirrhosis]; no mention of hepatic decompensation or deaths from liver disease).
Mangia A, Foster GR, Berg CP, Curescu M, Ledinghen V, Habersetzer F, Manolakopoulos S, et al. (2017). PegBase Group Investigators. Efficacy and safety profile of boceprevir-or telaprevir-based triple therapy or dual peginterferon alfa-2a or alfa-2b plus ribavirin therapy in chronic hepatitis C: the real-world PegBase observational study. Ann Gastroenterol. (Among 4100 patients with chronic hepatitis C, genotype 1, enrolled in an international database and treated with triple therapy of peginterferon [alfa-2a or alfa-2b], ribavirin, and either boceprevir or telaprevir, SVR rates ranged from 57% to 65% and were lower in those with cirrhosis [41% vs 66%], while serious adverse events included hepatic failure [n=4: 0.1%, 1.1% of cirrhotics], serious infections [45: 1.1%] and death [11: 0.2%]).
Callefi LA, Villela-Nogueira CA, de Barros Tenore S, Carnaúba-Júnior D, Coelho HSM, Pinto PTA, Nabuco LC, et al. (2017). Effectiveness and safety of first-generation protease inhibitors in real-world patients with hepatitis C virus genotype 1 infection in Brazil: a multicenter study. Clinics (Sao Paulo). (Among 715 Brazilian patients with chronic hepatitis C treated at 15 medical centers with peginterferon, ribavirin and either boceprevir [n=158] or telaprevir [n=557], the SVR rate was 57%, those with cirrhosis having a lower SVR [47% vs 71%] and higher severe adverse event rate [51% vs 35%], which included hepatic decompensation in 18 patients [4% of total, 6.6% of cirrhotics]).

## OTHER REFERENCE LINKS

1 Recent References on Boceprevir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Boceprevir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Boceprevir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Boceprevir)